# Clemastine

## OVERVIEW

### Introduction

Clemastine is a first generation antihistamine that is used for symptoms of allergic rhinitis and the common cold. Clemastine has not been linked to instances of clinically apparent acute liver injury.

### Background

Clemastine (kle mas' teen) is a first generation antihistamine that is used for alleviation of symptoms of allergic rhinitis, the common cold and allergic urticaria, including sneezing, cough, runny note, watery eyes and itching. Clemastine belongs to the ethanolamine class of antihistamines (with diphenhydramine and dimenhydrinate) and was first approved for use in the United States in 1977. Clemastine is available in multiple generic forms as tablets and syrup, many of which are available without prescription. Common brand names include Tavist Allergy and Dayhist Allergy. The recommended adult oral dose ranges from 1 to 2 mg one to three times daily. Common side effects include sedation, impairment of motor function, confusion, dizziness, blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Despite widespread use, the first generation antihistamines such as clemastine have rarely been linked to liver test abnormalities or to clinically apparent liver injury. The reason for their safety may relate to low daily dose and limited duration of use.

Likelihood score: E (unlikely to be a cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Clemastine – Generic, Dayhist Allergy®, Tavist Allergy®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Clemastine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Clemastine | 15686-51-8 | C21-H26-Cl-N-O | Clemastine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Clemastine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Clemastine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Clemastine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Clemastine)